# Pyrantel

## OVERVIEW

### Introduction

Pyrantel is a nonabsorbed anthelmintic agent with activity against intestinal nematodes such as pinworms and roundworms. Pyrantel therapy has not been reported to cause serum aminotransferase elevations or clinically apparent liver injury.

### Background

Pyrantel (pi ran' tel) is a pyrimidine derivative which is believed to act by depolarizing the neuromuscular junction of nematodes, resulting in their paralysis and expulsion in stool. The drug is poorly absorbed from the intestine and is usually effective in a single dose. Pyrantel is currently available in the United States over-the-counter as tablets of 720 mg (250 mg pyrantel base) and in a suspension of 144 mg/mL (50 mg pyrantel base/mL) under the brand name Antiminth or Pin-X. It is recommended for pinworm infection due to Enterobius vermicularis and Ascaris lumbricoides. The typical dose in both adults and children is 11 mg/kg (up to 1 g) as a single dose, which can be repeated in two weeks. Pyrantel is widely used in veterinary medicine. Side effects are uncommon, mild and transient and include nausea, gastrointestinal upset and headache.

### Hepatotoxicity

Pyrantel therapy has not been clearly associated with elevations in serum aminotransferase levels nor has its use been linked to cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pyrantel is minimally absorbed and given in single doses only, perhaps accounting for its lack of hepatotoxicity as currently used.

### Outcome and Management

Pyrantel is usually well tolerated and clinically apparent liver injury has not been reported.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pyrantel – Generic, Antiminth®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pyrantel)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pyrantel | 15686-83-6 | C11-H14-N2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2020

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintic written in 1999; pyrantel is not discussed).
Keiser J, McCarthy J, Hotez P. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-9. (Textbook of pharmacology and therapeutics).
Keiser J, Utzinger J. (2008). Efficacy of current drugs against soil-transmitted helminth infections: systematic review and meta-analysis. JAMA. (Pyrantel pamoate is effective against A. Lumbricoides and possibly N. Americanus; side effects are mainly abdominal pain, nausea and dizziness).
St Georgiev V. (2001). Pharmacotherapy of ascariasis. Expert Opin Pharmacother. (Ascariasis can be treated with mebendazole, albendazole and pyrantel pamoate; a single dose of pyrantel has a cure rate of 95-100%; reported to cause mild serum enzyme elevations in children).
Van Riper G. (1993). Pyrantel pamoate for pinworm infestation. Am Pharm. (Review: pyrantel is the only over-the-counter medication for pinworms [Enterobius vermicularis] and also has activity against the common roundworm [Ascaris lumbricoides]; recommended dose is 11 mg/kg given once or twice [2 weeks apart]; side effects are minimal and transient).
(2013). Drugs for parasitic infections. Treat Guidel Med Lett. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects; pyrantel can be helpful in treatment of pinworm [Enterobius] and whipworm [Trichostrongylus] infection; side effects can include gastrointestinal upset, headache, dizziness, rash and fever).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an anthelmintic, mebendazole; none were attributed to pyrantel).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 409 [46%] were attributed to antimicrobial agents, but none to anthelmintics or to pyrantel).

## OTHER REFERENCE LINKS

1 [underlined: Recent References on Pyrantel: from PubMed.gov] (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pyrantel/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 [underlined: Trials on Pyrantel: from ClinicalTrials.gov] (https://clinicaltrials.gov/ct2/results?term=Pyrantel)